# Tribulus

## OVERVIEW

### Introduction

Tribulus is herbal product prepared from the leaves, fruit and roots of Tribulus terrestris, extracts of which have been used as an aphrodisiac, general tonic and mood stimulant in traditional medicine. The native plant causes serious liver injury in grazing animals, and but tribulus extracts have not been linked convincingly to instances of clinically apparent liver injury when given in typical doses in humans.

### Background

Tribulus is prepared from the leaves and roots of the low-growing shrub and common weed Tribulus terrestris that is found in dry habitats in many parts of the world, including Asia, Africa, Australia and North and South America. Extracts of the shrub have been used in traditional medicine as an aphrodisiac, general tonic and mood stimulant for centuries. A major use of tribulus has been for sexual dysfunction such as erectile dysfunction in men and hypoactive sexual syndromes in women, but also for menopausal symptoms, premenstrual syndrome and infertility. Recently tribulus has been used commonly for increasing athletic performance. Tribulus is also purported to be beneficial for several other medical conditions, including urinary tract infections, kidney stones, hypertension, angina pectoris, hypercholesterolemia, gastrointestinal disorders, diarrhea and even liver disease. Studies in animal models suggested that tribulus increases testosterone levels in males and estrogen levels in females, but these hormonal effects have not been reproduced consistently in humans. Furthermore, in controlled trials, improvements in sexual function were no greater with Tribulus terrestris extracts than with placebo. The active ingredients in extracts of tribulus are believed to be saponins such as dioscine, diosgenin and protodioscin which are steroidal molecules and thought to increase levels of sex hormones. Tribulus is available in tablets and capsules of 250 and 500 mg, and the usual daily dose is 250 to 750 mg daily. Tribulus terrestris is also included in many multi-ingredient dietary supplements used for sexual dysfunction and body building. Tribulus is reported to be well tolerated but may be associated with mild gastrointestinal discomfort, nausea or dyspepsia. The plant, also known as puncture vine because of the sharp spines on its fruit, has been linked to outbreaks of liver injury in grazing animals known as geeldikkop or hepatogenous photosensitivity. The toxic component of the plant is believed to be the steroidal sapogenins which form crystals in bile ducts and renal tubules in sheep that feed upon its leaves.

### Hepatotoxicity

Tribulus terrestris has been not been reported to cause serum enzyme elevations in persons taking the herbal extract, but prospective studies with regular monitoring of liver tests have not been done. Isolated case reports of renal injury with serum aminotransferase elevations have been published but may have represented instances of ischemic or anabolic steroid induced liver and kidney injury rather than direct hepatotoxicity of the extract. Interestingly, the Tribulus terrestris plant is known to be toxic to grazing animals and can cause distinctive liver injury known as “geeldikkop” or hepatogenous photosensitivity. Histology of the liver from sheep dying after feeding upon the leaves of Tribulus terrestris demonstrates crystals in bile ducts and renal tubules. For these reasons, high doses should be considered potentially injurious, particularly in patients with preexisting liver disease or cirrhosis.

Likelihood score: E* (unproven but possible rare cause of clinically apparent liver injury when taken in high doses or in persons with pre-existing liver disease).

Other names: Puncture vine, Devil’s Thorn, Goathead, Gokhru, Nature’s Viagra, Protodioscine

### Mechanism of Injury

Leaf extracts of Tribulus contain many components, but none has been shown to be particularly hepatotoxic in humans. In grazing animals Tribulus terrestris has been linked to bile duct injury and the toxic component of the plant is believed to be steroidal sapogenins which form crystals in bile ducts and renal tubules.

### Outcome and Management

Clinically apparent liver injury from Tribulus in humans has not been convincingly shown.

Drug Class: Herbal and Dietary Supplements

## CASE REPORT

### Case 1. Severe Jaundice and Renal Dysfunction in a Patient Taking Tribulus.(1)

A 30 year old man developed weakness, nausea and poor appetite a few months after starting Tribulus terrestris extract tablets (once daily) as a part of his body building program. He began to feel poorly and over the next 6 weeks lost 50 pounds in weight, eventually developing pruritus and jaundice and seeking medical attention. He had no history of liver disease and drank alcohol only occasionally. His only other medications were naproxen for headaches and protein shakes for nutrition. Laboratory tests showed a total bilirubin of 36 mg/dL (direct 18.7 mg/dL), ALT 90 U/L, AST 49 U/L and alkaline phosphatase 219 U/L. Tests for hepatitis A, B and C and HIV infection were negative as was the ANA. Abdominal ultrasound showed a homogenous but enlarged liver but no evidence of biliary obstruction. A liver biopsy showed severe cholestasis, no inflammation and no bile duct injury or fibrosis. Tribulus was stopped and he was treated with ursodiol. He was discharged but then readmitted 2 weeks later with persistent jaundice (bilirubin 39 mg/dL) and an increase in serum creatinine from 1.1 to 3.1 mg/dL. One month after the second admission he was seen as an outpatient and both liver and kidney tests had improved.

#### Key Points

Medication: | Tribulus terrestris tablets once daily ~2 months
Pattern: | Bland cholestasis
Severity: | 4+ (jaundice, hospitalization, renal dysfunction)
Latency: | ~2 months
Recovery: | Improvement reported in 6 weeks.
Other medications: | Protein shakes, naproxen, ?anabolic steroids

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Creatinine (mg/dL) | Other
2 months | 0 | 90 | 219 | 36.0 | 1.1 | Admission, tribulus stopped
| 1 week | | | | 1.5 | Discharged, on ursodiol
| 2 weeks | 59 | 278 | 39.0 | 3.1 | Readmission, kidney biopsy
4 months | 6 weeks | 126 | | 4.4 | 1.2 | Clinic follow up
Upper Limit of Normal | | 40 | 147 | 1.2 | 1.2

#### Comment

While this published case was thought to represent Tribulus terrestris induced liver and renal injury, it was much more likely to have been due to unacknowledged use of anabolic steroids for body building. The clinical history, laboratory tests and course are typical of anabolic steroid jaundice, which usually presents with severe pruritus and jaundice in an otherwise healthy young male body builder who may or may not admit to use of anabolic steroids. The pattern of liver enzymes is usually a mild-to-moderate increase in serum aminotransferase levels and normal or only minimal increase in alkaline phosphatase despite the marked increase in serum bilirubin. Liver biopsy shows severe canalicular cholestasis with minimal cell injury or inflammation (bland cholestasis) and no fibrosis. Patients with serum bilirubin levels above 30 mg/dL can develop bilirubin nephropathy with bilirubin stained casts. The liver and renal injury can be severe, but are self-limiting and eventually resolve without evidence of chronic injury to either the liver or kidneys. Because anabolic steroids are illegal drugs, patients may refuse to admit that they were being used.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tribulus – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://www.nccih.nih.gov/health/providers/digest/dietary-supplements-marketed-for-weight-loss-bodybuilding-and-sexual-enhancement-science)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tribulus | 90131-68-3 | Herbal | Not Applicable

## CITED REFERENCE

1 Ryan M, Lazar I, Nadasdy GM, Nadasdy T, Satoskar AA. (2015). Acute kidney injury and hyperbilirubinemia in a young male after ingestion of Tribulus terrestris. Clin Nephrol.

## ANNOTATED BIBLIOGRAPHY

References updated: 08 August 2022

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not tribulus).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; tribulus is not discussed).
Bourke CA. (1983). Hepatopathy in sheep associated with Tribulus terrestris. Aust Vet J. (3 sheep developed diarrhea and weight loss 15 days after starting a diet of 8 kg of Tribulus plants daily, dying within 5 weeks with jaundice and autopsy showing hepatic fibrosis, bile duct proliferation and crystals in bile ducts).
Glastonbury JR, Doughty FR, Whitaker SJ, Sergeant E. (1984). A syndrome of hepatogenous photosensitisation, resembling geeldikkop, in sheep grazing Tribulus terrestris. Aust Vet J. (Two outbreaks of jaundice and photosensitization were reported in sheep both linked to grazing on Tribulus terrestris, autopsies showing needle-like clefts and crystalline material in bile ducts and kidney tubules).
Button C, Paynter DI, Shiel MJ, Colson AR, Paterson PJ, Lyford RL. (1987). Crystal-associated cholangiohepatopathy and photosensitisation in lambs. Aust Vet J. (Four outbreaks of crystal associated cholangiohepatopathy and photosensitization in lambs not thought to be attributable to Tribulus terrestris [AST 82-859 U/L, Alk P 126 to 175 U/L, bilirubin 0.4 to 13.4 mg/dL] and not affecting mature sheep; possibly due to Panicum schinzii).
Tapia MO, Giordano MA, Gueper HG. (1994). An outbreak of hepatogenous photosensitization in sheep grazing Tribulus terrestris in Argentina. Vet Hum Toxicol. (Description of an outbreak of liver disease in sheep grazing on Tribulus terrestris in Argentina which resembled the photosensitivity and liver injury of sheep described in Australia).
McDonough SP, Woodbury AH, Galey FD, Wilson DW, East N, Bracken E. (1994). Hepatogenous photosensitization of sheep in California associated with ingestion of Tribulus terrestris (puncture vine). J Vet Diagn Invest. (A flock of 7 sheep in the US developed reddening of the skin and bright yellow mucous membranes [bilirubin 1.2 mg/dL, AST 767 U/L, Alk P 380 U/L, GGT 451 U/L], autopsy showing spotty hepatocyte necrosis, periductal concentric fibrosis and crystals in bile ducts).
Ukani MD, Nanavati DD, Mehta NK. (1997). A review on the ayurvedic herb tribulus terrestris L. Anc Sci Life. (Tribulus, also known as Gokhshura, is used in several Ayurvedic herbs, largely as a diuretic).
Brown GA, Vukovich MD, Sharp RL, Reifenrath TA, Parsons KA, King DS. (1999). Effect of oral DHEA on serum testosterone and adaptations to resistance training in young men. J Appl Physiol. (In a controlled trial of DHEA vs placebo in 19 young men, DHEA increased serum androstenedione levels but testosterone, estradiol, lipids and liver enzymes were not affected and there was no improvement in strength and lean body mass in response to resistance training when compared to placebo).
Antonio J, Uelmen J, Rodriguez R, Earnest C. (2000). The effects of Tribulus terrestris on body composition and exercise performance in resistance-trained males. Int J Sport Nutr Exerc Metab. (Among 15 healthy resistance trained men treated with Tribulus terrestris or placebo and undergoing an 8 week weight training period, there were no differences in changes in muscle strength or body composition between the two groups).
Brown GA, Vukovich MD, Reifenrath TA, Uhl NL, Parsons KA, Sharp RL, King DS. (2000). Effects of anabolic precursors on serum testosterone concentrations and adaptations to resistance training in young men. Int J Sport Nutr Exerc Metab. (Among 20 subjects treated with the combination of androstenedione, Tribulus terrestris, DHEA, Chrysin, indole-3-carbinol and saw palmetto and underwent resistance training for 8 weeks, there were no differences in changes in weight, lean body mass, strength, serum testosterone, insulin resistance and serum glucose, ALT or AST between the two groups).
Mason MA, Giza M, Clayton L, Lonning J, Wilkerson RD. (2001). Use of nutritional supplements by high school football and volleyball players. Iowa Orthop J. (Among 495 male high school football players, 42 [8%] reported taking dietary supplements to enhance athletic performance [usually creatine and amino acids] including 1 who was taking tribulus).
Brown GA, Vukovich MD, Martini ER, Kohut ML, Franke WD, Jackson DA, King DS. (2001). Endocrine and lipid responses to chronic androstenediol-herbal supplementation in 30 to 58 year old men. J Am Coll Nutr. (Controlled trial of androstenediol and herbal supplements vs placebo for 4 weeks in 56 men found and increase in free but no change in total testosterone levels and no changes in serum ALT levels).
Rowland DL, Tai W. (2003). A review of plant-derived and herbal approaches to the treatment of sexual dysfunctions. J Sex Marital Ther. (Review of herbal approaches to treating sexual dysfunction).
Aslani MR, Movassaghi AR, Mohri M, Pedram M, Abavisani A. (2003). Experimental Tribulus terrestris poisoning in sheep: clinical, laboratory and pathological findings. Vet Res Commun. (Among 6 sheep fed Tribulus terrestris, all developed photosensitivity after 11 days, with jaundice and liver histology showing fibrosis and crystalloid material in bile ducts and renal tubules).
Pittler MH, Ernest E. (2003). Systematic review: hepatotoxic events associated with herbal medicinal products. Aliment Pharmacol Ther. (Systematic review of published cases of hepatotoxicity due to herbal medications listing 52 case reports or case series, most common agents being celandine [3], chaparral [3], germander [8], Jin Bu Huan [3], kava [1], Ma huang [3], pennyroyal [1], skullcap [2], Chinese herbs [9], valerian [1]).
Estes JD, Stolpman D, Olyaei A, Corless CL, Ham JM, Schwartz JM, Orloff SL. (2003). High prevalence of potentially hepatotoxic herbal supplement use in patients with fulminant hepatic failure. Arch Surg. (Among 20 patients undergoing liver transplantation for acute liver failure during 2001-2, 10 were potentially caused by herbals, but none attributed to Tribulus terrestris).
McKay D. (2004). Nutrients and botanicals for erectile dysfunction: examining the evidence. Altern Med Rev. (Review of herbals used for erectile dysfunction; Tribulus has been claimed to increase dehydroepiandrosterone [DHEA] levels, but it has not been objectively studied in humans for either safety or efficacy in improving sexual function or athletic performance).
Neychev VK, Mitev VI. (2005). The aphrodisiac herb Tribulus terrestris does not influence the androgen production in young men. J Ethnopharmacol. (Among 22 men treated with tribulus or placebo for 4 weeks, serum levels of testosterone, androstenedione and luteinizing hormone did not change).
Rogerson S, Riches CJ, Jennings C, Weatherby RP, Meir RA, Marshall-Gradisnik SM. (2007). The effect of five weeks of Tribulus terrestris supplementation on muscle strength and body composition during preseason training in elite rugby league players. J Strength Cond Res. (A controlled trial of Tribulus terrestris vs placebo in 22 male rugby players for 5 weeks found no difference in gain in muscular strength, body composition or testosterone/epitestosterone levels).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, none due to aloe vera).
Navarro VJ. (2009). Herbal and dietary supplement hepatotoxicity. Semin Liver Dis. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS; aloe vera is listed as a potential hepatotoxin but not specifically discussed).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry found no cases attributed to Tribulus terrestris).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not Tribulus).
Talasaz AH, Abbasi MR, Abkhiz S, Dashti-Khavidaki S. (2010). Tribulus terrestris-induced severe nephrotoxicity in a young healthy male. Nephrol Dial Transplant. (28 year old man developed seizures and fatigue 2 days after starting drinking 2 L of Tribulus terrestris water daily [creatinine 17.4 mg/dL, ALT 40 times ULN], resolving with stopping over the next 2 weeks).
Schmidt M, Thomsen M, Bone K. (2011). Tribulus terrestis-induced nephrotoxicity?. Nephrol Dial Transplant. (Letter questioning the association of tribulus ingestion with the injury reported by Talasaz [2010]).
Ho CC, Tan HM. (2011). Rise of herbal and traditional medicine in erectile dysfunction management. Curr Urol Rep. (Review of herbals used for erectile dysfunction: Tribulus is advertised as being an aphrodisiac, but “there have been no studies yet on humans”).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, noni juice, Chinese herbs, vitamin A and anabolic steroids; Tribulus terrestris is not discussed).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements but none contained Tribulus).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the General population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, 15 of which [16%] were attributed to HDS products, but none were listed as containing Tribulus terrestris).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury does not discuss Tribulus terrestris).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products including 1 linked with aloe vera in combination with 2 other agents).
Navarro VJ, Lucena MI. (2014). Hepatotoxicity induced by herbal and dietary supplements. Semin Liver Dis. (Review of the international regulatory framework for HDS products and the epidemiology, clinical presentation, diagnosis and cause of HDS associated liver injury with tables and discussion of the most commonly implicated agents, but tribulus is not mentioned).
Rossi S, Navarro VJ. (2014). Herbs and liver injury: a clinical perspective. Clin Gastroenterol Hepatol. (Review of frequency, diagnosis and causes of liver injury from herbal products discusses kava, black cohosh, pyrrolizidine alkaloids, flavocoxid, glucosamine, saw palmetto, green tea, usnic acid and several proprietary herbal mixtures but not tribulus).
Santos CA, Reis LO, Destro-Saade R, Luiza-Reis A, Fregonesi A. (2014). Tribulus terrestris versus placebo in the treatment of erectile dysfunction: A prospective, randomized, double blind study. Actas Urol Esp. (Among 30 healthy men with erectile dysfunction treated with Tribulus terrestris [800 mg] or placebo daily for 30 days, there were no differences in changes in sexual function or testosterone levels between the two groups; adverse events and serum ALT levels during therapy were not mentioned).
Akhtari E, Raisi F, Keshavarz M, Hosseini H, Sohrabvand F, Bioos S, Kamalinejad M, et al. (2014). Tribulus terrestris for treatment of sexual dysfunction in women: randomized double-blind placebo - controlled study. Daru. (Among 60 women with hypoactive sexual desire disorder treated with Tribulus terrestris [7.5 mg daily] or placebo for 4 weeks, those on Tribulus had greater improvements in desire, arousal, lubrication and satisfaction while adverse events were similar in the two treatment groups).
Ryan M, Lazar I, Nadasdy GM, Nadasdy T, Satoskar AA. (2015). Acute kidney injury and hyperbilirubinemia in a young male after ingestion of Tribulus terrestris. Clin Nephrol. (Healthy 30 year old man developed fatigue, weight loss, pruritus and jaundice 6 weeks after starting Tribulus terrestris as a body building supplement [bilirubin 36 mg/dL, ALT 90 U/L, Alk P 291 U/L], biopsy demonstrating bland cholestasis, with subsequent worsening and renal dysfunction [bilirubin 39 mg/dL, creatinine 3.1] but ultimate recovery; most likely due to illicit anabolic steroid use rather than Tribulus).
West E, Krychman M. (2015). Natural aphrodisiacs-A review of selected sexual enhancers. Sex Med Rev. (Review of the most popular aphrodisiac products marketed in the US mentions that it contains protodioscin which is converted to dehydroepiandrosterone and has been studied for effects on sexual dysfunction in women and has been well tolerating causing only minor gastrointestinal side effects; no mention of ALT levels or hepatotoxicity).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of herbal associated liver injury does not discuss Tribulus specifically).
Cui T, Kovell RC, Brooks DC, Terlecki RP. (2015). A urologist's guide to ingredients found in top-selling nutraceuticals for men's sexual health. J Sex Med. (Description and assessment of over-the-counter nutraceuticals used for male sexual dysfunction mentions that Tribulus was found in 43% of 30 products identified in doses ranging from 100 to 1000 mg and that controlled studies have found no evidence for its efficacy in improving men’s sexual health and there have been two reports of renal and liver toxicity in young healthy men taking high doses).
Postigo S, Lima SM, Yamada SS, dos Reis BF, da Silva GM, Aoki T. (2016). Assessment of the effects of Tribulus terrestris on sexual function of menopausal women. Rev Bras Ginecol Obstet. (Among 60 postmenopausal women with sexual dysfunction treated with Tribulus terrestris [750 mg daily] or placebo for 90 day, sexual function improved to a greater extend in the Tribulus treated patients and common adverse events included diarrhea [13%], dizziness [10%] and nausea [10%], no mention of ALT levels or hepatotoxicity).
de Souza KZ, Vale FB, Geber S. (2016). Efficacy of Tribulus terrestris for the treatment of hypoactive sexual desire disorder in postmenopausal women: a randomized, double-blinded, placebo-controlled trial. Menopause. (Among 45 healthy postmenopausal women with diminished libido treated with Tribulus terrestris [750 mg daily] or placebo for 120 days, sexual desire and function improved to the same degree in both groups, although there was a minimal increase in serum testosterone levels; 3 patients dropped out of both groups because of nausea; no mention of other adverse events, ALT levels or hepatotoxicity).
Roaiah MF, Elkhayat YI, Abd El Salam MA, Din SFG. (2017). Prospective analysis on the effect of botanical Meme (Tribulus terrestris) on serum testosterone level and semen parameters in males with unexplained infertility. J Diet Suppl. (Among 30 men with infertility treated with Tribulus terrestris [750 mg daily] or placebo for 3 months, there were no changes in testosterone and LH levels nor in semen quality; no mention of adverse events).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products, Tribulus is not listed).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], while none were attributed to Tribulus).
Borrelli F, Colalto C, Delfino DV, Iriti M, Izzo AA. (2018). Herbal dietary supplements for erectile dysfunction: a systematic review and meta-analysis. Drugs. (Systematic review of the literature on herbal products used for erectile dysfunction mentions that two trials of Tribulus terrestris reported improvements in sexual function and one did not; no discussion of adverse events).
Sellami M, Slimeni O, Pokrywka A, Kuvačić G, D, Hayes L, Milic M, Padulo J. (2018). Herbal medicine for sports: a review. J Int Soc Sports Nutr. (Review of natural products used to enhance athletic performance mentions Tribulus terrestris contains saponins which may increase testosterone levels and improve physical fitness, but the medical literature demonstrates mixed results and high doses [above 1000 mg daily] may have significant side effects).
Vale FBC, Zanolla Dias de Souza K, Rezende CR, Geber S. (2018). Efficacy of Tribulus Terrestris for the treatment of premenopausal women with hypoactive sexual desire disorder: a randomized double-blinded, placebo-controlled trial. Gynecol Endocrinol. (Among 40 premenopausal women with diminished libido treated with Tribulus terrestris [750 mg daily] or placebo for 120 days, sexual function improved in both groups to a similar degree, and serum testosterone levels did not change; no mention of adverse events, but dropout rate was 38%).
GamalEl Din SF. (2019). Tribulus terrestris versus placebo in the treatment of erectile dysfunction and lower urinary tract symptoms in patients with late-onset hypogonadism: A placebo-controlled study. Urologia. (Among 70 “aging” men with erectile dysfunction and lower urinary tract symptoms treated with Tribulus terrestris daily for 3 months, total testosterone levels increased and sexual function was improved, while adverse events were rare and serum AST levels increased minimally [26.5 to 27.8 U/L]).
Ștefănescu R, Tero-Vescan A, Negroiu A, Aurică E, Vari CE. (2020). A Comprehensive review of the phytochemical, pharmacological, and toxicological properties of Tribulus terrestris L. Biomolecules. (Review of the phytochemical and toxicological features of Tribulus terrestris [spike fruit] mentions that it is a crawling herbal plant that grows in arid climates and sandy soils, extracts of which have been used in Chinese and Ayurvedic medicine and are generally well tolerated and that contamination or variation in local phytochemistry may account for occasional reports of toxicity).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while none were attributed to Tribulus terrestris).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62], and greater celandine [48]; there were no cases attributed to Tribulus terrestris).
Vale FBC, Boroni JD, Geber G, Antunes EMG, Bretas T, Lopes GP, Geber S. (2021). Effect of Tribulus terrestris in the treatment of female sexual dysfunction and clitoral vascularization. results of a randomized study comparing two different dosage regimes. J Sex Marital Ther. (Among 85 pre and post-menopausal women with sexual dysfunction treated with Tribulus terrestris in doses of 280 mg once daily or 94 mg three times daily for 90 days, symptoms of sexual function improved and serum levels of free testosterone levels increased while clitoral vascularization did not change).

## OTHER REFERENCE LINKS

1 Recent References on Tribulus: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Tribulus+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Tribulus: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tribulus)